# Opicapone

## OVERVIEW

### Introduction

Opicapone is a catechol-O-methyltransferase inhibitor that is used as adjunctive therapy to levodopa/carbidopa in patients with Parkinson disease experiencing difficulty with “off” episodes when motor symptoms breakthrough on treatment. Opicapone has been associated with a minimal rate of serum enzyme elevations during therapy and has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Opicapone (oh pik’ a pone) is a catechol O-methyltransferase (COMT) inhibitor that blocks the peripheral metabolism of levodopa and prolongs its serum half-life and effectiveness in providing dopamine to the brain. Levodopa/carbidopa is the mainstay of therapy of Parkinson disease, increasing brain dopamine levels and typically alleviating the motor symptoms of Parkinson disease for 5 to 6 hours. After the first 2 to 5 years of therapy, however, the duration of benefit becomes shorter (wearing off effect), and patients develop fluctuations between mobility and immobility (on-off effect). Opicapone, by slowing the metabolism of levodopa increases its duration of action. In several prospective randomized, placebo controlled trials, opicapone was found to decrease the duration of wake “off” time episodes and increase the amount of “on” time. Opicapone was approved for use as adjunctive therapy to levodopa and carbidopa for adults with Parkinson disease who experienced off episodes in 2020. Opicapone is currently available in capsules of 25 and 50 mg under the brand name Ongentys. The recommended dose is 50 mg once daily. While opicapone may improve control of symptoms, there is no evidence that it slows the progression of Parkinson disease. Common side effects include dyskinesia, dizziness, constipation, nausea, daytime sleepiness, and insomnia. Less common but potentially severe adverse events include hallucinations, psychotic and compulsive behaviors, hypersexuality, and severe dyskinesia. Abrupt discontinuation of opicapone can be followed by a withdrawal symptoms of hyperpyrexia and confusion.

### Hepatotoxicity

In prelicensure controlled trials, serum ALT elevations occurred uncommonly in opicapone-treated subjects and in rates similar to that of placebo controls. In studies of more than 1000 patients treated with opicapone there were no instances of serious hepatic events and no relevant changes in serum enzymes. After its approval and more widespread use, there have been no reports clinically apparent liver injury attributable to opicapone. There has, however, been limited clinical experience with its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Opicapone was the third COMT inhibitor approved as adjuvant therapy with levodopa in patients with Parkinson disease who were experiencing motor complications (“off” episodes). The initial COMT inhibitor approved for use was tolcapone, which was associated with a high rate of marked serum aminotransferase elevations during therapy and subsequently with several reports of clinically apparent liver injury. For that reason, tolcapone is subjected to a strict monitoring program in which regular testing of serum aminotransferase levels is strongly advised. Because opicapone has not been found to cause aminotransferase elevations, regular monitoring is not required or even recommended. The reasons for the relative safety of opicapone in comparison to tolcapone are unclear. Opicapone is metabolized by sulfonylation and glucuronidation rather than by the cytochrome P450 microsomal enzymes (CYP).

### Outcome and Management

Opicapone has been not been linked to serum enzyme elevations during therapy. Discontinuation for serum enzyme elevations is rarely necessary, but should be done if the elevations are accompanied by symptoms or jaundice or for ALT elevations of more than 5 times the upper limit of normal (ULN). There is no information on cross sensitivity to liver injury between opicapone and other agents used in the therapy of Parkinson disease.

Drug Class: Parkinson Disease Agents

Other Drugs in the Subclass, COMT Inhibitors: Entacapone, Tolcapone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Opicapone – Ongentys®

DRUG CLASS

Parkinson Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Opicapone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Opicapone | 923287-50-7 | C15-H10-Cl2-N4-O6

## ANNOTATED BIBLIOGRAPHY

References updated: 25 October 2021

Abbreviations used: COMT, catechol O-methyltransferase; CPK, creatine phosphokinase; MAO, monoamine oxidase.

Roberson ED. Parkinson Disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 328-333. (Textbook of pharmacology and therapeutics; COMT inhibitors are discussed).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/212489Orig1s000MedR.pdf (FDA website, including product label and clinical review of data submitted in support of approval of opicapone, mentions that therapy is associated with a minimal rate of ALT elevations which was comparable to that of placebo [<1%], that elevations above 3 times ULN were rare, and there were no cases with concurrent bilirubin elevations).
Ferreira JJ, Lees A, Rocha JF, Poewe W, Rascol O, Soares-da-Silva P. (2016). Bi-Park 1 investigators. Opicapone as an adjunct to levodopa in patients with Parkinson's disease and end-of-dose motor fluctuations: a randomised, double-blind, controlled trial. Lancet Neurol. (Among 600 adults with Parkinson disease with motor fluctuations while on levodopa who were treated with opicapone [5, 25, or 50 mg], entacapone [200 mg], or placebo once daily for 14-15 weeks, “off” time decreased by 60 minutes in the 50 mg dose group in comparison to placebo, which was non-inferior to entacapone, and total adverse event rates were similar in the three groups [54% vs 57% and 50%], dyskinesia was more frequent with opicapone [16% vs 8% and 4%] and “changes in laboratory tests…differed by <2% across visits for any treatment groups”).
Lees AJ, Ferreira J, Rascol O, Poewe W, Rocha JF, McCrory M, Soares-da-Silva P, BIPARK-2 Study Investigators. (2017). Opicapone as adjunct to levodopa therapy in patients With Parkinson disease and motor fluctuations: a randomized clinical trial. JAMA Neurol. (Among 427 adults with Parkinson disease and motor fluctuations while on levodopa treated with opicapone [25 or 50 mg] vs placebo for 14-15 weeks and then in an open phase with opicapone for one year, “off” time decreased 102 to 118 minutes with opicapone vs 65 minutes with placebo, and effects were maintained for the full year, while total adverse event rates were 71% vs 64%, dyskinesia rates 24% vs 8% and “no relevant liver function finding occurred in either phase”).
Lees A, Ferreira JJ, Rocha JF, Rascol O, Poewe W, Gama H, Soares-da-Silva P. (2019). Safety profile of opicapone in the management of Parkinson's disease. J Parkinsons Dis. (Analysis of pooled results of controlled trials and open label studies of opicapone as an adjunct for Parkinson disease [1614 patients] identified total adverse event rates for opicapone [25 and 50 mg daily combined] vs placebo to be 63.5% vs 57.5%, serious adverse events 3.5% vs 4.3%, dyskinesia 18.3% vs 6.2%, constipation 5.7% vs 1.9%, insomnia 5.1% vs 1.6%, CPK elevations 3.9% vs 1.9%, dizziness 3.7% vs 1.2%, somnolence 2.9% vs 1.9%, hallucinations 1.8% vs 0.4%, and that there were no relevant changes in liver enzymes and no serious hepatic adverse events).
Ferreira JJ, Lees A, Rocha JF, Poewe W, Rascol O, Soares-da-Silva P. (2019). Long-term efficacy of opicapone in fluctuating Parkinson's disease patients: a pooled analysis of data from two phase 3 clinical trials and their open-label extensions. Eur J Neurol. (Pooled results of two placebo-controlled trials of opicapone in adults with Parkinson disease and motor complications yielded an overall average decrease in “off” time compared to placebo of -35 minutes for the 25 mg dose and -58 minutes for the 50 mg dose with an accompanying increase in “on” time without worsening of dyskinesia; no information provided on safety results).
Reichmann H, Lees A, Rocha JF, Magalhães D, Soares-da-Silva P, OPTIPARK investigators. (2020). Effectiveness and safety of opicapone in Parkinson's disease patients with motor fluctuations: the OPTIPARK open-label study. Transl Neurodegener. (Among 495 adults with Parkinson disease and motor fluctuations on levodopa therapy who were treated in an open label trial of opicapone [50 mg daily] in Germany for 3 months and the UK for 6 months, subjective improvement was reported in 71-85% of patients while the overall adverse event rate was 75%, serious adverse event rate 6.9%, and discontinuation rate for treatment relate adverse events 13%; no mention of ALT elevations or serious hepatic adverse events).
Scott LJ. (2021). Opicapone: a review in Parkinson's disease. CNS Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and tolerance of opicapone, the third COMT inhibitor approved in the US [having been approved in Europe in 2016], specifically comments that in clinical trials, it has no clinically relevant hepatobiliary adverse events).
(2021). Opicapone (Ongentys) - a COMT inhibitor for Parkinson's disease. Med Lett Drugs Ther. (Concise review of mechanism of action, clinical efficacy, safety and costs of opicapone shortly after its approval for use in Parkinson disease, mentions adverse events of dyskinesia, constipation, creatine phosphokinase [CPK] elevations, hypotension, syncope, weight loss, drowsiness, hallucinations, delusions, agitation and withdrawal symptoms; mentions specifically that it has not been associated with hepatotoxicity).
Drugs for Parkinson's disease. (2021). Med Lett Drugs Ther. (Concise review of current medications approved for use in Parkinson disease including levodopa/carbidopa, dopamine agonists, COMT inhibitors, monoamine oxidase [MAO]-B inhibitors, anticholinergics, and istradefylline, mentions hepatotoxicity of tolcapone but not of opicapone or any other of the adjunctive therapies).

## OTHER REFERENCE LINKS

1 Recent References on Opicapone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Opicapone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Opicapone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Opicapone)